# Vitamin B

## OVERVIEW

### Introduction

Vitamin B refers to several water soluble vitamins often found together in foods, all of which are necessary for normal growth and metabolism, but none of which are synthesized in adequate amounts by humans. The common forms of vitamin B include vitamin B1 (thiamine), B2 (riboflavin), B3 (niacin), B6 (pyridoxine) and B12 (cyanocobalamin). Except for niacin (when given in high doses), there is no evidence that the other B vitamins, in physiologic or even super-physiologic high doses cause liver injury or jaundice. The major forms of vitamin B and selected other water soluble vitamins (biotin, pantothenic acid, choline) are discussed briefly in this record.

### Vitamin B1, Thiamine

Thiamine (or thiamin) (thye' a min) is a water soluble B vitamin found in whole grains, legumes, yeast, beef and pork. Thiamine was the first B vitamin to be discovered and was given the designation vitamin B1. Thiamine is required in amino acid and carbohydrate metabolism and is active in energy generation reactions. Thiamine deficiency is rare, but can occur in malnourished patients due to chronic alcoholism or cancer chemotherapy with poor dietary intake. More recently, symptomatic thiamine deficiency has been reported in women with hyperemesis gravidarum, patients after gastric bypass surgery and in malnourished patients with intestinal obstruction or malabsorption syndromes. Populations and cultures that rely heavily upon rice based diets are at increased risk of thiamine deficiency. Classic diet related thiamine deficiency causes the symptom complex known as beriberi (“weak, weak”), marked by variable degrees of weight loss, nausea and vomiting, diarrhea, irritability, apathy, muscle weakness and painful peripheral neuropathy. Cardiac dysfunction with right sided heart failure and peripheral edema can also occur and is called “wet” beriberi. Thiamine deficiency can also present with prominent central nervous system symptoms (Wernicke-Korsakoff syndrome), particularly in malnourished patients with chronic alcoholism or on cancer chemotherapy. Wernicke encephalopathy is characterized by mental deterioration, nystagmus, ophthalmoplegia and ataxia; Korsakoff’s syndrome is marked by memory loss, confabulation and psychosis. Acute thiamine deficiency can also cause lactic acidosis. Thiamine is highly water soluble and body stores are not great, for which reason deficiencies can develop rapidly (within weeks to months). The recommended dietary allowance of thiamine is 1.2 mg in adult men and 1.1 mg in adult women, amounts that are provided in the average American diet. Thiamine is available generically in many over-the-counter forms and is included in virtually all multivitamin preparations (typically in concentrations of 0.3 to 1.5 mg). Parenteral thiamine is available (100 mg/mL) and used in parenteral nutrition and to treat suspect thiamine deficiencies, often given routinely to hospitalized patients admitted with complications of chronic alcoholism. Oral forms of thiamine have not been associated with adverse events, ALT elevations or liver injury even when given in high doses. Parenteral administration of thiamine can be associated with immediate hypersensitivity reactions including anaphylaxis, but these are rare (<1:1000). Thus, neither oral nor parenteral high dose thiamine administration has been linked to serum enzyme elevations or to instances of clinically apparent liver injury.

Likelihood score: E (unlikely cause of liver injury).

### Vitamin B2, Riboflavin

Riboflavin (rye' boe flay vin) is a water soluble B vitamin found in milk and dairy products, whole grains, legumes, lean meat and fish. Riboflavin is important in fat, carbohydrate and protein metabolism and is a central component in flavin adenine dinucleotide (FAD), a component of many enzymes that require electron transfer. Riboflavin deficiency is rare, but can occur with severe malnutrition and chronic alcoholism and usually presents with nonspecific symptoms including weakness, sore throat, mucositis, cheilosis, glossitis, dermatitis and anemia. Several foods are fortified with riboflavin including bread, cereals and milk. The recommended dietary allowance is 1.3 mg for adult men and 1.1 mg for women, which are well within the amounts found in a typical American diet. Riboflavin is available over-the-counter in multiple forms and is included in most multivitamin preparations in typical concentrations of 0.3 to 1.7 mg. Riboflavin is yellow in color, has natural fluorescence and is inactivated by light. Oral forms of riboflavin have not been associated with adverse events, ALT elevations or hepatotoxicity even when given in high doses. One reason why high doses of riboflavin are well tolerated is that oral doses above 30 mg are not absorbed, and what riboflavin is absorbed is rapidly excreted and body stores are generally limited.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Vitamin B3, Niacin

Niacin (nye' a sin) is a water-soluble B vitamin found in many foodstuffs, particularly fresh vegetables, milk, meat and eggs. Cereal grains and bread are often fortified with niacin. Chemically niacin is known as nicotinic acid and its amide as nicotinamide, both of which are precursors of two important co-enzymes, nicotinamide adenine dinucleotide (NAD) and its phosphate (NADP), which are important in oxidative and reductive reactions and in DNA repair. Niacin deficiency is the cause of pellagra which is now found largely among malnourished alcoholics, but was previously epidemic in populations dependent upon corn based diets. Symptoms of pellagra (“sour skin”) include dermatitis, diarrhea, depression, seizures and dementia. The recommended daily allowance of niacin for adults is 16 mg in men and 14 mg in women. Unlike other B vitamins, niacin has been linked to instances of clinically apparent liver injury, but only when given as niacin and in very high doses. Doses of niacin and nicotinamide used in multivitamins and as vitamin supplements (typically ~20 mg) and the higher doses used to treat pellagra (100-200 mg of nicotinamide three times daily) have not been linked to ALT elevations or to clinically apparent liver injury. Niacin (nicotinic acid) in high doses causes a decrease in serum cholesterol and is used to treat dyslipidemia, using concentrations in the range of 1.5 to 6.0 grams daily (100 to 400 times the RDA). Niacin at these dose levels and particularly the long acting formulations have been linked to a distinctive and severe form of liver injury typically presenting after several months of therapy with marked elevations in serum aminotransferase levels and with early features of hepatic failure. The latency to onset can be quite long (6 months to several years), but there is often a history of recent increase in dose or change in niacin formulation (to a sustained release form). Recovery upon withdrawal is rapid. Further discussion and examples of liver injury due to high dose niacin are provided in the section on niacin which can be reached using the link below.

Likelihood score: A[HD] (well known cause of clinically apparent liver injury, but only when given in high doses).

### Vitamin B6, Pyridoxine

Pyridoxine (pir" i dox' een) is a water soluble B vitamin found in many foodstuffs, but in highest concentrations in meat, legumes and nuts. Pyridoxine actually represents a family of related compounds including pyridoxine, pyridoxal, pyridoxamine and their phosphates, which are the active coenzyme forms of vitamin B6. Pyridoxine acts as a cofactor in many enzyme systems, particularly in amino acid metabolism and heme synthesis. The recommended dietary allowance for pyridoxine is 1.3 to 2.0 mg for adults, a level that is well within that provided in typical American diets. Pyridoxine deficiency is rare, but can occur with severe malnutrition and chronic alcoholism. Symptoms of deficiency include weakness, fatigue, dermatitis, cheilosis and anemia. Certain medications including isoniazid, L-dopa, penicillamine and cycloserine interact with vitamin B6 and can cause deficiency. For that reason, these drugs are often given with pyridoxine supplementation (10 to 25 mg daily). Pyridoxine is available over-the-counter in multiple forms and concentrations and is included in virtually all multivitamin preparations, typically in concentrations of 2 to 3 mg. High doses of pyridoxine (50 to 500 mg daily) have been recommended to treat carpal tunnel syndrome, schizophrenia, autism and diabetes, but the efficacy in these conditions is not proven. Oral forms of pyridoxine (below 100 mg daily) have not been associated with adverse events, ALT elevations or hepatotoxicity. Prolonged use of high doses has been linked to sensory neuropathy and to occasional symptoms of nausea, gastrointestinal upset and dermatitis, but not to liver injury.

In contrast, pyridoxal-5’-phosphate which is used to treat genetic disorders of pyridoxal phosphate metabolism has been linked to serum enzyme elevations when given in high doses which can result in chronic hepatitis, cirrhosis and even hepatocellular carcinoma. These abnormalities of pyridoxine metabolism typically present in infancy with refractory seizures than respond to pyridoxine or pyridoxal phosphate. These abnormalities do not recur when patients are switched to pyridoxine (which is not always effective), but do recur when pyridoxal phosphate is restarted. Pyridoxal phosphate is not approved for use in the United States but can be obtained under special circumstances.

Likelihood score: E (unlikely cause of liver injury).

### Vitamin B12, Cobalamin

Cyanocobalamin (sye" an oh koe bal' a min) is a water soluble B vitamin found in dairy products and meat. The cobalamins are complex organometallic compounds with a central cobalt atom within a porphyrin-like corrin ring. Cobalamins act as essential cofactors for several enzymes including methionine synthase and methylmalonyl-coenyzme A-mutase. The activities of these enzymes are important in RNA, protein and lipid metabolism and in hemoglobin synthesis. Cobalamin cannot be synthesized by humans and its presence in meat and eggs is due to its synthesis by microorganisms in the intestines of animals. Vitamin B12 absorption from the diet requires a cofactor (intrinsic factor) produced by parietal cells of the stomach. The major cause of cobalamin deficiency in humans is lack of intrinsic factor due to gastric atrophy caused by autoimmune destruction of parietal cells. Classic vitamin B12 deficiency causes profound anemia and symptoms of anorexia, irritability, apathy, weakness and a distinctive neurologic syndrome with paresthesias in the hands and feet, unsteady gait, moodiness, confusion and memory loss. The recommended daily dietary allowance of vitamin B12 is 2.4 µg in adults which is well within the concentrations found in the average American diet. Normal serum levels range from 200 to 900 pg/mL (150 to 660 picomoL). Vitamin B12 is available in multiple over-the-counter oral forms and it is included in most multivitamin preparations in typical concentrations of 1 to 6 µg. Parenteral formulations are available by prescription and treatment of vitamin B12 deficiency usually requires parenteral administration, typically in doses of 1000 µg intramuscularly once monthly. Neither oral nor parenteral forms of vitamin B12 have been linked to significant side effects or toxicity. The parenteral forms can cause local injection reactions and hypersensitivity and should be given intramuscularly or by deep subcutaneous injection and not intravenously. Vitamin B12 therapy has not been linked to ALT elevations or to clinically apparent acute liver injury.

Likelihood score: E (unlikely cause of liver injury).

### Biotin

Biotin (bye' oh tin) is a water soluble vitamin (also known as vitamin B7, formerly vitamin H) and is found in liver, soy, beans and egg yolks. Egg whites, however, contain the protein avidin that binds to biotin and reduces its availability. Biotin acts as a carrier of carbon dioxide and plays a role in carboxylase enzymes involved in gluconeogenesis and fatty acid metabolism. The recommended daily dietary allowance for biotin has not been formally established, but the amounts needed are small and biotin is found in many foods and is produced by intestinal bacteria. An adequate intake for biotin has been estimated as 30 µg daily. Thus, most diets provide adequate amounts of biotin and its deficiency is rare. Biotin deficiency has occurred in humans on parenteral nutrition. Symptoms include hair loss, seborrheic dermatitis, depression, hallucinations and paresthesias. Biotin is available generically in many over-the-counter forms in doses of 5 to 10 mg and is included in most multivitamin preparations, usually in concentrations of 30 to 300 µg. Biotin is typically added to parenteral nutrition and the doses for deficiencies is in the range of 10 mg daily. Biotin supplements have no known adverse events and have not been linked to ALT elevations or hepatotoxicity.

Likelihood score: E (unlikely cause of liver injury).

### Pantothenic Acid

Pantothenic acid (pan" toe then' ik as’ id) is a water soluble vitamin (also known as vitamin B5) that is found in many foods including vegetables, eggs, liver and yeast. Pantothenic acid is a component of coenzyme A and is involved in fatty acid and cholesterol metabolism and synthesis of steroid hormones. Pantothenic acid deficiency has been produced experimentally and causes gastrointestinal disturbance, muscle cramps, paresthesias, ataxia, depression and hypoglycemia. It may be the cause of burning feet syndrome, experienced by prisoners of war. Pantothenic acid deficiency occurs largely as a component of mixed, severe malnutrition with combined vitamin deficiencies. The recommended dietary allowance of pantothenic acid has not been formally established, but the dietary reference adequate intake is 5 mg daily in adults. Pantothenic acid is available generically in many over-the-counter forms and is included in most multivitamin preparations, typically in concentrations ranging from 1 to 10 mg. Pantothenic acid supplementation has not been associated with adverse events, ALT elevations or liver injury even when given in high doses.

Likelihood score: E (unlikely cause of liver injury).

### Choline

Choline (koe' leen) is a precursor of acetylcholine, phospholipids and betaine and is necessary for the structural integrity of cell membranes and cholinergic neurotransmission. Choline is not considered a vitamin because it is synthesized in the mammalian liver. However, the amounts derived from de novo synthesis are not thought to be adequate for normal nutrition. Choline is widely distributed in many foodstuffs and particularly liver, milk, eggs and peanuts. The recommended adequate intake was been estimated to be 550 mg daily in men and 425 mg in women, levels which are regularly met by typical American diets. Choline deficiency can be created in experimental animals and causes fatty liver, which is often used as an experimental model for alcoholic and non-alcoholic fatty liver disease. Whether choline deficiency is an important cause of fatty liver disease in humans is not known, but severe protein-calorie malnutrition is often accompanied by marked fatty liver and choline supplementation of total parenteral nutrition decreases fat accumulation in the liver. High levels of choline intake (above 3.5 grams daily) can cause hypotension, diarrhea, salivation, sweating and a fishy body odor. However, there have been no reports of liver injury or ALT elevations associated with high oral supplement of choline.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Drug Class: Vitamins

Other Drugs in the Class: Vitamin A, Vitamin C, Vitamin D, Vitamin E, Vitamin K, Folate, Niacin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Vitamin B1, Thiamine – Generic, Combination Products

Vitamin B2, Riboflavin – Generic, Combination Products

Vitamin B6, Pyridoxine – Generic, Combination Products

Vitamin B12, Cyanocobalamin – Generic, Combination Products

DRUG CLASS

Vitamins

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Vitamin+B)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Biotin | 58-85-5 | C10-H16-N2-O3-S
Choline | 62-49-7 | C5-H14-N-O
Cyanocobalamin | 68-19-9 | C63-H88-Co-N14-O14-P
Nicotinamide | 98-92-0 | C6-H6-N2-O
Pantothenic Acid | 79-83-4 | C9-H17-N-O5
Pyridoxine HCl | 58-56-0 | C8-H11-N-O3.Cl-H
Riboflavin | 83-88-5 | C17-H20-N4-O6
Thiamine HCl | 67-03-8 | C12-H17-N4-O-S.Cl-H.Cl

## ANNOTATED BIBLIOGRAPHY

References updated: 27 May 2021

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity published in 1999, does not discuss vitamin B or water soluble vitamins other than niacin).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp, 631-57. (Review of hepatotoxicity of dietary supplements; does not discuss vitamins and minerals).
Kaushansky K, Kipps TJ. Hematopoietic agents: growth factors, minerals and vitamins. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 751-68. (Textbook of pharmacology and therapeutics).
Shils ME, Olson JA, Shike M, Ross AC. Modern nutrition in health and disease. 9th ed. Baltimore: Williams & Wilkins, 1998. (Textbook of nutrition with separate chapters on each of the B vitamins).
Food and Nutrition Board, Institute of Medicine. DRI dietary reference intakes: for thiamin, riboflavin, niacin, vitamin B6, folate, vitamin B12, pantothenic acid, biotin and choline. Washington DC: National Academy Press, 1998. (Reports from the Food and Nutrition Board of the Institute of Medicine on reference values for vitamin intake, replacing the previously published Recommended Dietary Allowances).
Office of Dietary Supplements. https://ods.od.nih.gov/factsheets/list-all/ (Fact sheets on dietary supplements including B vitamins maintained and regularly updated by the Office of Dietary Supplements, National Institutes of Health).
Schaumburg H, Kaplan J, Windebank A, Vick N, Rasmus S, Pleasure D, Brown MJ. (1983). Sensory neuropathy from pyridoxine abuse. A new megavitamin syndrome. N Engl J Med. (27 year old woman developed difficulty walking and peripheral neuropathy 2 years after starting increasing doses of pyridoxine [to 5 g daily], resolving slowly and incompletely upon stopping; no mention of liver test results or hepatotoxicity).
Stephen JM, Grant R, Yeh CS. (1992). Anaphylaxis from administration of intravenous thiamine. Am J Emerg Med. (32 year old man developed nausea, diffuse skin erythema, shortness of breath and wheezing within minutes of receiving intravenous thiamine [100 mg], responding to corticosteroids, epinephrine and antihistamines).
Wrenn KD, Slovis CM. (1992). Is intravenous thiamine safe?. Am J Emerg Med. (Letter in response to Stephen [1992] mentioning the safety of intravenous thiamine, the authors estimating that among 10,000 injections given for alcoholism and malnutrition, they had not seen any significant allergic reactions or other side effects).
Johri S, Shetty S, Soni A, Kumar S. (2000). Anaphylaxis from intravenous thiamine--long forgotten?. Am J Emerg Med. (51 year old woman with confusion and alcoholism developed shock requiring intubation after receiving intravenous thiamine [100 mg] with recurrence on reexposure two days later).
Bendich A, Cohen M. (1990). Vitamin B6 safety issues. Ann N Y Acad Sci. (Review of the safety of pyridoxine in high doses including reports of neuropathy, which is typically reversible upon stopping and associated with use of more than 100 mg daily; no mention of ALT elevations or hepatotoxicity).
Gdynia HJ, Müller T, Sperfeld AD, Kühnlein P, Otto M, Kassubek J, Ludolph AC. (2008). Severe sensorimotor neuropathy after intake of highest dosages of vitamin B6. Neuromuscul Disord. (75 year old man developed gait disturbance and sensory neuropathy two years after starting high doses of pyridoxine [9.6 g daily] along with 100 other supplements with marked, but not complete recovery upon stopping).
Bender DA. (1999). Non-nutritional uses of vitamin B6. Br J Nutr. (Review of the non-nutritional uses and toxicity of pyridoxine mentions neuropathy, which arises usually with doses in excess of 200 mg daily; no mention of ALT elevations or hepatotoxicity).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to water soluble vitamins including niacin).
Sriram K, Manzanares W, Joseph K. (2012). Thiamine in nutrition therapy. Nutr Clin Pract. (Review of thiamine in nutrition, history of its discovery and complications of its deficiency).
Steinberg A, Gorman E, Tannenbaum J. (2014). Thiamine deficiency in stem cell transplant patients: a case series with an accompanying review of the literature. Clin Lymphoma Myeloma Leuk. (49 year old woman with acute leukemia underwent hematopoietic cell transplantation and developed diarrhea, weight loss, headaches and encephalopathy, responding to intravenous thiamine).
Stroh C, Meyer F, Manger T. (2014). Beriberi, a severe complication after metabolic surgery - review of the literature. Obes Facts. (Review of 255 published cases of thiamine deficiency after bariatric surgery).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 7 were attributed to niacin, but none were attributed to any other vitamin).
Isenberg-Grzeda E, Alici Y, Hatzoglou V, Nelson C, Breitbart W. (2016). Nonalcoholic thiamine-related encephalopathy (Wernicke-Korsakoff Syndrome) among inpatients with cancer: a series of 18 cases. Psychosomatics. (Over an 18 month period, 18 hospitalized patients receiving cancer chemotherapy were diagnosed with Wernicke-Korsakoff Syndrome, many with nausea, vomiting, weakness and lactic acidosis).
Yoshida I, Sakaguchi Y, Nakano M, Yamashita F, Hitoshi T. (1985). Pyridoxal phosphate-induced liver injury in a patient with homocystinuria. J Inherit Metab Dis. (7 year old boy with homocystinuria developed malaise and liver test abnormalities 2 months after starting high doses [500 to 1000 mg daily] of pyridoxal phosphate [ALT 228 Karmen units, Alk P 57.9 KA units, bilirubin not provided], which returned to normal within a month of stopping and did not recur with pyridoxine but did with restarting pyridoxal phosphate).
Sudarsanam A, Singh H, Wilcken B, Stormon M, Arbuckle S, Schmitt B, Clayton P, et al. (2014). Cirrhosis associated with pyridoxal 5'-phosphate treatment of pyridoxamine 5'-phosphate oxidase deficiency. JIMD Rep. (8 year old boy with pyridoxamine 5’ phosphate oxidase deficiency required high doses of pyridoxamine 5’ phosphate to control seizures [~100 mg/kg/day] and was found to have abnormal liver tests [ALT 169 U/L, GGT 131 U/L, prothrombin time 19 seconds, bilirubin not given] and cirrhosis on liver biopsy, liver tests improving with lowering of the dose).
Mills PB, Camuzeaux SS, Footitt EJ, Mills KA, Gissen P, Fisher L, Das KB, et al. (2014). Epilepsy due to PNPO mutations: genotype, environment and treatment affect presentation and outcome. Brain. (Description of 15 children with pyridoxine-5’-phosphate oxidase deficiency, two of whom developed liver function abnormalities when treated with pyridoxal-5-phosphate which improved but did not resolve when the dose was reduced; details not provided).
Wilson MP, Plecko B, Mills PB, Clayton PT. (2019). Disorders affecting vitamin B6 metabolism. J Inherit Metab Dis. (Review of genetic disorders associated with impairment of pyridoxal-5-phosphate metabolism which typically presents in childhood with severe seizures and is responsive to therapy with pyridoxal-5-phosphate, which at high doses has been linked to serum aminotransferase elevations that can lead to cirrhosis and hepatocellular carcinoma).
Sinha S, Kataria A, Kolla BP, Thusius N, Loukianova LL. (2019). Wernicke encephalopathy-clinical pearls. Mayo Clin Proc. (Clinical review of the clinical features of Wernicke encephalopathy which is associated with alcoholism but also cancer chemotherapy, malabsorption syndromes, intestinal obstruction, hyperemesis gravidarum, and gastric bypass surgery, and is treated with high doses of thiamine given parenterally which is safe even in doses of 600 mg daily).
Calderon-Ospina CA, Nava-Mesa MO, Paez-Hurtado AM. (2020). Update on safety profiles of vitamins B1, B6, and B12: a narrative review. Ther Clin Risk Manag. (Review of the potential adverse reactions to use of high doses of thiamine [largely just rare mild-to-moderate infusion or hypersensitivity reactions], pyridoxine [neurotoxicity associated with prolonged use of high doses, usually reversible] and vitamin B12 [hip fractures and lung cancer, but relatedness is probably confounded by other factors including smoking]).
Cree BAC, Cutter G, Wolinsky JS, Freedman MS, Comi G, Giovannoni G, Hartung HP, et al. (2020). SPI2 investigative teams. Safety and efficacy of MD1003 (high-dose biotin) in patients with progressive multiple sclerosis (SPI2): a randomised, double-blind, placebo-controlled, phase 3 trial. Lancet Neurol. (Among 642 patients with progressive multiple sclerosis treated with oral biotin [100 mg] or placebo three times daily for 12 months, improvements in disability and walk time were similar in the two groups as were overall [84% vs 85%] and serious adverse event rates [26% vs 26%], and “serum chemistries… did not differ between groups”, but biotin did interfere with results of assays using biotinylated antibodies).
McLaughlin K, Joyal K, Lee S, Corrado M, Marquis K, Anger K, Szumita P. (2020). Safety of intravenous push thiamine administration at a tertiary academic medical center. J Am Pharm Assoc. (Among 8606 administrations of intravenous thiamine [100 to 500 mg] in 2595 patients given over a 2 year period, there were no instances of anaphylaxis and only rare [n=26] mild local infusion reactions).
da Silva JSV, Seres DS, Sabino K, Adams SC, Berdahl GJ, Citty SW, Cober MP, et al., Parenteral Nutrition Safety and Clinical Practice Committees, American Society for Parenteral and Enteral Nutrition. (2020). ASPEN consensus recommendations for refeeding syndrome. Nutr Clin Pract. (Description of clinical features and pathogenesis of refeeding syndrome and appropriate approach to its prevention, focusing upon use and monitoring of serum phosphate, potassium and magnesium and including use of thiamine; no mention of liver injury or hepatitis).
Coughlin CR, Tseng LA, Abdenur JE, Ashmore C, Boemer F, Bok LA, Boyer M, et al. (2021). Consensus guidelines for the diagnosis and management of pyridoxine-dependent epilepsy due to α-aminoadipic semialdehyde dehydrogenase deficiency. J Inherit Metab Dis. (Guidelines for management of children with pyridoxine-responsible epilepsy with ALDH7A1 deficiency recommends treatment with pharmacologic doses of pyridoxine [30 mg/kg/day] and possibly a lysine restricted diet, with monitoring for peripheral neuropathy; no mention of hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Vitamin B and Water Soluble Vitamins: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Vitamin+B/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2 Trials on Vitamin B and Water Soluble Vitamins: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Vitamin+B)